# Etoposide

## OVERVIEW

### Introduction

Etoposide and teniposide are semisynthetic analogues of podophyllotoxin that are used as antineoplastic agents in the therapy of several forms of solid tumors, leukemia and lymphoma, usually in combination with other agents. Both etoposide and teniposide are associated with an appreciable rate of serum enzyme elevations during therapy, and high doses have been implicated in causing clinically apparent acute liver injury including sinusoidal obstruction syndrome.

### Background

Etoposide (e toe' poe side) and teniposide (ten" i poe' side) are semisynthetic derivatives of podophyllotoxin, an extract from the mandrake plant (American May Apple: Podophyllum peltatum). Both drugs appear to act by binding to and inhibiting topoisomerase II, preventing the healing of DNA breaks that occur during the action of this enzyme in replicating cells. Both agents have antineoplastic activity in vitro and in animal models, and were introduced into clinical practice in the 1980s and 1990s as a part of combination chemotherapy for various leukemias, lymphomas and solid tumors. Etoposide (also known as VP-16) was approved for use in the United States in 1983 and teniposide (VP-26) in 1992. Current formal indications for etoposide include refractory testicular tumors and small cell lung cancer to be used in combination with other agents. Etoposide is available as a solution or lyophilized powder for injection in vials of varying concentrations, and as capsules of 50 mg for oral administration in generic forms and under the commercial name Toposar. The typical dose of etoposide varies by indication and is adjusted for body weight and renal function. The current single approved indication for teniposide is refractory childhood acute lymphoblastic leukemia in combination with other anticancer agents. Teniposide is available in solution in 50 mg vials generically and under the trade name Vumon. The typical dose varies by body weight. Side effects of etoposide and teniposide are similar and include bone marrow suppression, nausea, vomiting, abdominal pain, stomatitis, diarrhea, fatigue, hypotension, allergic reactions, hair loss and peripheral neuropathy. Uncommon, but potentially severe adverse reactions include severe myelosuppression, neutropenic fever or sepsis and anaphylactic reactions. Both agents should be administered only by physicians with experience in the use of chemotherapeutic agents and management of their toxicities.

### Hepatotoxicity

Chemotherapy with etoposide or teniposide in combination with other agents is associated with serum enzyme elevations in 5% to more than 50% of patients, depending upon the dose and other agents used. The ALT elevations are usually asymptomatic and transient and may resolve without dose modification. In many instances, it is difficult to attribute the liver test abnormalities to etoposide or teniposide because of the exposure to other potentially hepatotoxic agents. Rare instances of clinically apparent liver injury have been reported in patients receiving etoposide, but the time to onset and pattern of injury has varied greatly. Onset can be as short as 1 to as long as 5 months after initiation of therapy. Some published cases of liver injury after regimens of chemotherapy that have included etoposide appear to represent sinusoidal obstruction syndrome. These cases have usually followed etoposide therapy in combination with an alkylating agent or total body irradiation. In addition, etoposide has been linked to cases of acute hepatitis arising after 1 to 5 months of treatment, which have generally been self-limiting, but occasionally severe. The role of etoposide in causing injury was not always clear. The pattern of serum enzyme elevation in reported cases has been hepatocellular. Immunoallergic features (rash, fever, eosinophilia) and autoantibodies were absent. The liver histology of etoposide hepatotoxicity has not been well characterized. The hepatotoxicity of teniposide has been less well defined than that of etoposide, probably because it has had limited use.

Likelihood score, etoposide: C (probable cause of clinically apparent liver injury).

Likelihood score, teniposide: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Etoposide is metabolized by the microsomal P450 drug metabolizing enzymes and inhibits the function of CYP 3A and 2D6, and injury may be the result of its activation to a toxic intermediate. Rapid recurrence with rechallenge is typical, but features of hypersensitivity are uncommon. In high doses, etoposide and teniposide may have direct hepatotoxic effects.

### Outcome and Management

The hepatic injury caused by etoposide is usually reversible and etoposide has not been linked to cases of prolonged cholestasis or vanishing bile duct syndrome. The results of rechallenge after cases of clinically apparent insult have not been reported. Liver injury due to teniposide has been even less well characterized and there is no information on cross sensitivity to adverse events between these two agents.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Topoisomerase Inhibitors: Irinotecan, Topotecan

## CASE REPORT

### Case 1. Acute hepatitis attributed to etoposide therapy.

[Modified from Case 1 in: Tran A, Housset C, Boboc B, Tourani JM, Carnot F, Berthelot P. Etoposide (VP 16-213) induced hepatitis. Report of three cases following standard-dose treatments. J Hepatol 1991; 12: 36-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/2007774)]

A 52 old year man with metastatic small cell lung cancer developed jaundice at the start of a third course of chemotherapy. His liver tests were known to have been normal when he was initially diagnosed with lung cancer with cerebral metastases. He was started on combination chemotherapy with vindesin (a vinca alkaloid), cis-platinum, cyclophosphamide, adriamycin, methylprednisolone and etoposide (308 mg/m^2^). His liver tests were still normal two weeks later, but were mildly abnormal when he started a second course (Table). A third course was started one month later, but he was found to be jaundiced the following day, blood tests showing a total bilirubin of 12.5 mg/dL, ALT 2270 U/L, AST 1680 U/L and alkaline phosphatase 181 U/L. He drank alcohol but not to excess and had no previous history of liver disease. During the first two courses of chemotherapy, he had received 4 units of red blood cells. Serological testing showed the presence of anti-HBc without HBsAg or IgM anti-HBc and absence of IgM anti-HAV, anti-CMV and anti-EBV. Tests for hepatitis C were not available (before 1991). A liver biopsy showed acute hepatitis with numerous eosinophils and areas of focal necrosis. Chemotherapy was discontinued. Jaundice resolved spontaneously and all liver tests returned to normal during the following 10 weeks. A fourth course of chemotherapy was given without etoposide. His serum aminotransferase levels remained normal.

#### Key Points

Medication: | Etoposide
Pattern: | Hepatocellular (R=28.3)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 3 months
Recovery: | 10 weeks
Other medications: | Vindesin, cis-platinum, cyclophosphamide, adriamycin, methylprednisolone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | Normal | Normal | Normal
2 weeks | Pre | 49 | 48 | 0.8 | At end of 1st course
1 month | Pre | 155 | 126 | | Before 2nd course
2 months | 0 | 2270 | 181 | 13.0
4 months | 10 weeks | Normal | Normal | Normal
Normal Values | | <40 | <90 | <1.2

#### Comment

This was one of three cases of acute hepatitis attributed to etoposide therapy. All three had a similar signature of an acute hepatitis arising after 2 to 5 months of cyclic chemotherapy, including use of intravenous, standard dose etoposide. The difficulty is that other diagnoses were possible for each of the three cases. Thus, the hepatitis C virus was first described in 1989 and serological tests were not available until 1991, well after these three patients had acute hepatitis. Furthermore, molecular tests for hepatitis B were not particularly sensitive (polymerase chain reaction tests were not available until the mid-1990s). Thus, the cases may have represented acute hepatitis C or reactivation of chronic hepatitis B, both of which this patient may have had (blood transfusions, preexisting anti-HBc reactivity). Other cases of an acute hepatitis-like syndrome have not been reported with etoposide, the majority of examples of hepatotoxicity being serum enzyme or bilirubin elevations or sinusoidal obstruction syndrome.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Etoposide – Generic, Toposar®

Teniposide – Generic, Vumon®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Teniposide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Etoposide | 33419-42-0 | C29-H32-O13 | Etoposide Chemical Structure
Teniposide | 29767-20-2 | C32-H32-O13-S | Teniposide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 February 2018

Zimmerman HJ. Edipophyllotoxins. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 692. (Expert review of hepatotoxicity published in 1999 mentions that AST and Alk P elevations can occur with therapy, and that cases of clinically apparent liver injury attributed to etoposide and teniposide have been published).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Epipodophyllotoxins. Cytotoxic agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1715-6. (Textbook of pharmacology and therapeutics: mentions that leucopenia is the dose limiting toxicity of etoposide, but that "Hepatic toxicity is particularly evident after high-dose treatment").
Muggia FM, Selawry OS, Hansen HH. Clinical studies with a new podophyllotoxin derivative, epipodophyllotoxin, 4'-demethyl-9-(4,6-O-2-thenylidine-D-glucopyranoside) (NSC-122819). Cancer Chemother Rep 1971; 55: 575-81. (Preliminary study of etoposide in 24 patients with advanced cancer found leukopenia the major side effect and AST elevations on single occasions in 4 patients [17%]). 4946082
Radice PA, Bunn PA Jr, Ihde DC. Therapeutic trials with VP-16-213 and VM-26: active agents in small cell lung cancer, non-Hodgkin's lymphomas, and other malignancies. Cancer Treat Rep 1979; 63: 1231-9. (Overview of the history, pharmacology, antitumor activity, clinical efficacy and safety of etoposide and teniposide; the major dose limiting side effect of both drugs was hematologic; "Mild LFT elevations" occurred in 8 of 44 patients [18%] treated with teniposide; no mention of clinically apparent liver injury). 225026
Van Echo DA, Wiernik PH, Aisner J. High-dose VP 16-213 (NSC 141540) for the treatment of patients with previously treated acute leukemia. Cancer Clin Trials 1980; 3: 325-8. (Among 13 patients with acute leukemia treated with high doses of intravenous etoposide, transient liver test abnormalities occurred during 3 of 17 courses [peak bilirubin 8.3 mg/dL, AST 66 U/L, Alk P 500 U/L], all returning to normal within 2 weeks). 6933027
Johnson DH, Greco FA, Wolff SN. Etoposide-induced hepatic injury: a potential complication of high-dose therapy. Cancer Treat Rep 1983; 67: 1023-4. (Two men, ages 23 and 25 years, with metastatic cancer developed jaundice after a 4th and 5th course of high dose etoposide [bilirubin 4.7 and 8.6 mg/dL, AST 249 and 1230 U/L, Alk P 211 and 900 U/L], resolving within 12 weeks in both). 6315228
Wolff SN, Johnson DH, Hainsworth JD, Greco FA. High-dose VP-16-213 monotherapy for refractory germinal malignancies: a phase II study. J Clin Oncol 1984; 2: 271-4. (Among 11 patients with refractory germ cell tumors treated with high doses of etoposide, 2 patients [18%] developed "severe but reversible hepatitis" [Johnson 1983]). 6368760
O'Dwyer PJ, Leyland-Jones B, Alonso MT, Marsoni S, Wittes RE. Etoposide (VP-16-213). Current status of an active anticancer drug. N Engl J Med 1985; 312: 692-700. (Review of the antitumor activity, mechanism of action, pharmacology, clinical efficacy and safety of etoposide; hepatotoxicity is not discussed). 2983208
Bork E, Hansen M, Dombernowsky P, Hansen SW, Pedersen AG, Hansen HH. Teniposide (VM-26), an overlooked highly active agent in small-cell lung cancer. Results of a phase II trial in untreated patients. J Clin Oncol 1986; 4: 524-7. (Among 36 patients with lung cancer treated with multiple standard dose 5 day cycles of teniposide every 3 weeks, the dose limiting toxicity was hematologic, nausea was "negligible" and "no allergic, neurologic or organ disturbances were noted"). 3007684
Wolff SN. High-dose carmustine and high-dose etoposide: a treatment regimen resulting in enhanced hepatic toxicity. Cancer Treat Rep 1986; 70: 1464-5. (Among 4 patients who received high dose carmustine [BCNU] and etoposide followed by autologous bone marrow transplantation for recurrent astrocytoma, 3 developed hepatotoxicity after 1-2 months, 2 with progressive jaundice, ascites and thrombocytopenia and one with transient ascites, suggestive of sinusoid obstruction syndrome). 3791261
Paschke R, Worst P, Brust J, Queisser W. [Hepatotoxicity with etoposide-ifosfamide combination therapy]. Onkologie 1988; 11: 273-5. German. (57 and 68 year old men with lung cancer developed jaundice 3-10 days after a course of etoposide and ifosfamide [bilirubin 22.6 and 12.3 mg/dL, AST 76 and 47 U/L, Alk P 225 and 218 U/L], being fatal in one and resolving in the other; possibly due to sepsis). 2853857
Paciucci PA, Davis RB, Holland JF, Martelo O, Schiffer CA. Mitoxantrone and constant infusion etoposide for relapsed and refractory acute myelocytic leukemia. Am J Clin Oncol 1990; 13: 516-9. (Among 32 patients treated in a dose finding study with mitoxantrone and etoposide, 13 [41%] developed hepatotoxicity which was severe, but not fatal, in two; no details provided). 2239806
Tran A, Housset C, Boboc B, Tourani JM, Carnot F, Berthelot P. Etoposide (VP 16-213) induced hepatitis. Report of three cases following standard-dose treatments. J Hepatol 1991; 12: 36-9. (2 women and 1 man, ages 52-76 years, with lung cancer developed acute hepatitis 2-5 months after starting cyclic chemotherapy with multiple agents, including standard doses of etoposide [bilirubin 1.3-13.0 mg/dL, ALT 790-2270 U/L, Alk P 175-280 U/L], resolving in 1-6 months in all three). 2007774
Vaughan WP, Dennison JD, Reed EC, Klassen L, McGuire TR, Sanger WG, Kumar PP, et al. Improved results of allogeneic bone marrow transplantation for advanced hematologic malignancy using busulfan, cyclophosphamide and etoposide as cytoreductive and immunosuppressive therapy. Bone Marrow Transplant 1991; 8: 489-95. (Among 24 patients with hematologic malignancies undergoing bone marrow transplant and chemotherapy with busulfan, cyclophosphamide and etoposide, 4 [17%] developed sinusoidal obstruction syndrome which was fatal in one). 1790429
Jeremic B, Grujicic D, Jevremovic S, Stanisavljevic B, Milojevic L, Djuric L, Mijatovic L. Carboplatin and etoposide chemotherapy regimen for recurrent malignant glioma: a phase II study. J Clin Oncol 1992; 10: 1074-7. (Among 38 patients with malignant glioma treated with carboplatin and etoposide, 4 [11%] had transient AST elevations [all less than 5 times ULN]). 1318951
Berenberg JL, Tangen C, Macdonald JS, Barlogie B, Laufman LR. VM-26 in gastric cancer. A Southwest Oncology Group study. Invest New Drugs 1993; 11: 333-4. (Among 21 patients with advanced gastric cancer treated with 5 day cycles of teniposide every 21 days, granulocytopenia was severe and dose limiting in half, and 5 patients [24%] developed "mild or moderate hepatic enzyme elevations"). 8157475
Muggia FM. Teniposide: overview of its therapeutic potential in adult cancers. Cancer Chemother Pharmacol 1994; 34 Suppl: S127-33. (Review of efficacy of teniposide in adult leukemia, lymphoma, lung, brain, ovarian and bladder cancers; no discussion of toxicity or mention of ALT elevations or liver injury). 8070021
Lazarus HM, Gray R, Ciobanu N, Winter J, Weiner RS. Phase I trial of high-dose melphalan, high-dose etoposide and autologous bone marrow re-infusion in solid tumors: an Eastern Cooperative Oncology Group (ECOG) study. Bone Marrow Transplant 1994; 14: 443-8. (Among 26 patients with refractory cancers treated with high doses of melphalan and etoposide followed by autologous bone marrow transplantation, 6 [23%] had hepatotoxicity, but no details provided). 7994270
Broun ER, Nichols CR, Mandanas R, Salzman D, Turns M, Hromas R, Cornetta K, et al. Dose escalation study of high-dose carboplatin and etoposide with autologous bone marrow support in patients with recurrent and refractory germ cell tumors. Bone Marrow Transplant 1995; 16: 353-8. (Among 33 patients with germ cell cancer treated with high doses of carboplatin and etoposide followed by autologous bone marrow transplantation, all had ALT elevations which appeared to be dose related and due to etoposide). 8535306
Sanson M, Ameri A, Monjour A, Sahmoud T, Ronchin P, Poisson M, Delattre JY. Treatment of recurrent malignant supratentorial gliomas with ifosfamide, carboplatin and etoposide: a phase II study. Eur J Cancer 1996; 32A: 2229-35. (Among 36 patients with malignant glioma treated with 1 to 16 cycles of carboplatin, ifosfamide and etoposide, 1 had transient ALT elevations above 2.5 times ULN). 9038603
Ohtsu T, Sasaki Y, Igarashi T, Murayama T, Kobayashi Y, Tobinai K. Unexpected hepatotoxicities in patients with non-Hodgkin's lymphoma treated with irinotecan (CPT-11) and etoposide. Jpn J Clin Oncol 1998; 28: 502-6. (All 3 patients with refractory lymphoma treated with irinotecan and etoposide [topoisomerase I and II inhibitors] developed ALT elevations above 2.5 ULN and one developed jaundice, but all recovered). 9769785
Papadopoulos KP, Garvin JH, Fetell M, Vahdat LT, Garrett TJ, Savage DG, Balmaceda C, et al. High-dose thiotepa and etoposide-based regimens with autologous hematopoietic support for high-risk or recurrent CNS tumors in children and adults. Bone Marrow Transplant 1998; 22: 661-7. (Among 31 patients with brain tumors treated with high doses of etoposide [750-1500 mg/meter squared over 3 days] and thiotepa combined with either carboplatin or carmustine, all developed neutropenia and 12 [39%] had transient grade 3 hepatotoxicity, including one child with sinusoidal obstruction syndrome). 9818693
Fleming DR, Wolff SN, Fay JW, Brown RA, Lynch JP, Bolwell BJ, Stevens DA, et al. Protracted results of dose-intensive therapy using cyclophosphamide, carmustine, and continuous infusion etoposide with autologous stem cell support in patients with relapse or refractory Hodgkin's disease: a phase II study from the North American Marrow Transplant Group. Leuk Lymphoma 1999; 35: 91-8. (Among 131 patients with refractory Hodgkin disease treated with high dose etoposide, cyclophosphamide and carmustine, 9 developed grade 3 or 4 hepatotoxicity, including 6 [4%] with fatal sinusoidal obstruction syndrome). 10512166
Mok TS, Zee B, Chan AT, Yeo W, Yang WT, Yim A, Leung SF, et al. A phase II study of gemcitabine plus oral etoposide in the treatment of patients with advanced nonsmall cell lung carcinoma. Cancer 2000; 89: 543-50. (Among 46 patients with advanced lung cancer treated with intravenous gemcitabine and oral etoposide [40 mg daily for 14 days], AST elevations occurred in 4 patients, including 2 with severe reactivation of hepatitis B). 10931453
Sobecks RM, Daugherty CK, Hallahan DE, Laport GF, Wagner ND, Larson RA. A dose escalation study of total body irradiation followed by high-dose etoposide and allogeneic blood stem cell transplantation for the treatment of advanced hematologic malignancies. Bone Marrow Transplant 2000; 25: 807-13. (Among 16 patients with hematologic malignancies treated with 2 different levels of total body irradiation and high dose etoposide followed by hematopoetic stem cell transplantation, 1 developed fatal sinusoidal obstruction syndrome and 3 others had hyperbilirubinemia, perhaps due to sepsis). 10808200
Hijiya N, Gaynon P, Barry E, Silverman L, Thomson B, Chu R, Cooper T, et al. A multi-center phase I study of clofarabine, etoposide and cyclophosphamide in combination in pediatric patients with refractory or relapsed acute leukemia. Leukemia 2009; 23: 2259-64. (Among 25 children with refractory leukemia treated with different doses of clofarabine, etoposide and cyclophosphamide, 38% developed ALT elevations >5 times ULN). 19741725
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J. Drug-Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several cases were attributed to antineoplastic agents [such as mercaptopurine, cyclophosphamide, docetaxel, temozolomide, bortezomib and imatinib], but none to etoposide or teniposide). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 to melphalan and 1 to gemtuzumab). 20949552
Tamiya A, Matsumura A, Tsuji T, Morimoto M, Asami K, Okishio K, Shimizu S, et al. A pilot study of cisplatin and etoposide with and without radiotherapy for advanced malignant thymoma. Anticancer Res 2014; 34: 2023-7. (Among 11 patients with malignant thymoma treated with cisplatin, etoposide and radiotherapy with a median follow up of 5 years, progression-free survival was 38 months and major side effects were myelosuppression, febrile neutropenia, anorexia, nausea, vomiting and fatigue, with ALT elevations in only one patient that was transient and less than 5 times ULN). 24692742
Yuan P, Di L, Zhang X, Yan M, Wan D, Li L, Zhang Y, et al. Efficacy of oral etoposide in pretreated metastatic breast cancer: a multicenter phase 2 study. Medicine (Baltimore) 2015; 94: e774. (Among 75 women with refractory metastatic breast cancer treated with oral etoposide with repeated 10 day courses in cycles of 21 days, the median progression-free survival was 4.5 months and adverse events included myelosuppression, mucositis, nausea, vomiting and alopecia, with serum enzyme elevations arising in 8 patients [11%], but all were transient and less than 5 times ULN). 25929919
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2025754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, but none were linked to use of etoposide or teniposide).
Sen F, Tambas M, Ozkaya K, Guveli ME, Ciftci R, Ozkan B, Oral EN, et al. Concomitant etoposide and cisplatin provided improved survival compared with docetaxel and cisplatin in patients with locally advanced non-small cell lung cancer treated with chemoradiotherapy. Medicine (Baltimore) 2016; 95: e4280. (Among 105 patients with advanced NSCLC treated with cisplatin and radiation combined with etoposide vs docetaxel for a median of 27 months, overall survival was higher with etoposide [41 vs 20 months] while adverse event rates were similar, ALT elevations arising in no subjects on etoposide vs only 1 on docetaxel). 27472701
Reck M, Luft A, Szczesna A, Havel L, Kim SW, Akerley W, Pietanza MC, et al. Phase III randomized trial of ipilimumab plus etoposide and platinum versus placebo plus etoposide and platinum in extensive-stage small-cell lung cancer. J Clin Oncol 2016; 34: 3740-8. (Among 1132 patients with advanced NSCLC treated with etoposide with or without ipilumumab, overall survival rates were similar in the two groups, while adverse events were greater in those receiving ipilumumab, one subject dying of hepatic failure attributed to the monoclonal antibody treatment, no details provided). 27458307

## OTHER REFERENCE LINKS

1. Recent References on Teniposide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Etoposide+Teniposide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Teniposide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Teniposide)